# Enflurane

## OVERVIEW

### Introduction

Enfurane is a volatile anesthetic agent with an excellent safety record which was previously widely used, but has now been replaced by more modern volatile anesthetic agents. Case series and isolated case reports of severe acute liver injury similar to halothane hepatitis attributed to enflurane have been published, but are rare.

### Background

Enflurane (en flur' ane) is a previously widely used halogenated inhalation anesthetic agent similar to halothane, desflurane, sevoflurane and isoflurane. Enflurane has a somewhat slow onset of action and is, therefore, was used largely to maintain anesthesia after induction with other agents. Enflurane became available in 1972 but was withdrawn is no longer in use in the United States, having been replaced by other the more modern halogenated inhalation agents. Enflurane must be administered in a controlled situation by a properly trained and credentialed anesthesiologist or nurse anesthetist and is typically given in concentrations up to 1.5% to 4% with oxygen.

### Hepatotoxicity

Prospective, serial blood testing often demonstrates minor transient elevations in serum aminotransferase levels in the 1 to 2 weeks after major surgery and anesthesia. Appearance of ALT levels above 10 times the upper limit of normal, however, is distinctly unusual and points to significant hepatotoxicity. Clinically apparent, severe hepatic injury from enflurane has been reported but is very rare. The injury resembles halothane hepatotoxicity and is marked by acute elevations in serum aminotransferase levels (5- to 50-fold) and appearance of jaundice 2 to 21 days after surgery and anesthesia. There are usually minimal increases in alkaline phosphatase and gammaglutamyl transpeptidase levels. The liver injury is often preceded by a day or two of fever and may be accompanied by rash and eosinophilia. The acute liver injury may be self-limited and resolve within 4 to 8 weeks, but can be severe and associated with acute liver failure. A strong risk factor is previous exposure to any of the halogenated anesthetics and particularly a history of halothane hepatitis or unexplained fever and rash after anesthesia with one of these agents.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of enflurane hepatotoxicity is suspected to be similar to that of halothane and associated with creation of reactive intermediates of enflurane. Enflurane is metabolized to some extent by the microsomal drug metabolizing enzyme CYP 2E1 to a trifluoroacetylated reactive intermediate (TFA) that is capable of binding to multiple intracytoplasmic proteins forming potentially immunogenic adducts. The TFA adducts induce antibodies that can be detected in patients with enflurane- as well as halothane hepatotoxicity and are also found in a proportion of health care workers exposed to the volatile anesthetics.

### Outcome and Management

Severity ranges from mild and transient aminotransferase elevations without symptoms or other evidence of liver injury, to a self limited symptomatic acute hepatitis-like reaction to a severe, acute hepatic failure. The severity and prognosis may relate in part of patient age, being more severe in the elderly and both milder and less common in children. Obesity may also be both a predisposing factor and predictor of outcome. Chronic liver injury from enflurane exposure has not been described. Patients with enflurane induced hepatitis should be cautioned against future exposure to a fluorinated hydrocarbon anesthetic such as halothane, desflurane, isoflurane or sevoflurane.

Drug Class: Halogenated Anesthetics

Other drugs in the Class: Desflurane, Halothane, Isoflurane, Sevoflurane

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enflurane – Generic, Ethrane®

DRUG CLASS

Anesthetics, Halogenated

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=enflurane)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Enflurane | 13838-16-9 | C3-H2-Cl-F5-O | Enflurane chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 January 2018

Zimmerman HJ. Anesthetic agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 457-82. (Expert review of hepatotoxicity of anesthetic agents published in 1999; mentions that enflurane appears to be safer than halothane, but it has been implicated in at least 30 cases of hepatic injury with features similar to halothane hepatitis).
Kenna JG. Mechanism, pathology, and clinical presentation of hepatoxicity of anesthetic agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 403-422. (Review of liver injury from anesthetic agents; mentions the incidence of enflurane hepatotoxicity is much less than with halothane, in the order of 1:800,000 exposures but that clinical features of the injury are similar to those of halothane hepatitis).
Patel PM, Patel HH, Roth DM. General anesthetics and therapeutic gases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 527-564. (Textbook of pharmacology and therapeutics).
Van der Reis L, Askin SJ, Frecker GN, Fitzgerald WJ. Letter: Hepatic necrosis after enflurane anesthesia. JAMA 1974; 227: 76. (62 year old woman with unsuspected cirrhosis developed fever 19 days after cholecystectomy using enflurane with subsequent rises in AST [176 to 3000 U/L], LDH [310 to 2000 U/L] and bilirubin [4.8 to 25.5 mg/dL], multiorgan failure and death at day 30). 4859632
Denlinger JK, Lecky JH, Nahrwold ML. Hepatocellular dysfunction without jaundice after enflurane anesthesia. Anesthesiology 1974; 41: 86-7. (40 year old man developed fever 1 day after receiving enflurane anesthesia [peak bilirubin 1.2 mg/dL, ALT ~900 U/L, AST 370 U/L, eosinophils 6%], resolving within 1 month). 4834383
Douglas HJ, Eger EI 2nd, Biava CG, Renzi C. Hepatic necrosis associated with viral infection after enflurane anesthesia. N Engl J Med 1977; 296: 553-5. (17 year old boy developed fever 3 days and diarrhea 4 days after enflurane anesthesia with subsequent hepatic failure [bilirubin not given, AST 13,000 U/L, LDH 8700 U/L] and death, autopsy showing massive necrosis and herpes virus inclusions). 189190
Ona FV, Patanella H, Ayub A. Hepatitis associated with enflurane anesthesia. Anesth Analg 1980; 59: 146-9. (66 year old woman developed high fevers after 2nd anesthesia exposure to enflurane within a few weeks [bilirubin 0.9 rising to 2.6 mg/dL, ALT 300 U/L, Alk P 368 U/L], also received antibiotics, including cephalexin). 7189334
Lewis JH, Zimmerman HJ, Ishak KG, Mullick FG. Enflurane hepatotoxicity. A clinicopathologic study of 24 cases. Ann Intern Med 1983; 98: 984-92. (Review of 10 published and 48 unpublished (FDA, AFIP) reports of enflurane hepatotoxicity; 24 considered likely, mean age 46 years, 16 had previous exposures, onset of fever in few hours to days after exposure, jaundice onset in 3 days to 3 weeks, eosinophilia in 29%, ALT 279-8000 U/L, LDH 260-10,000 U/L, Alk P 1-5 times ULN, bilirubin 1.2-32 mg/dL, 3 patients developed renal failure and 5 died). 6859708
Sigurdsson J, Hreidarsson AB, Thjodleifsson B. Enflurane hepatitis. A report of a case with a previous history of halothane hepatitis. Acta Anaesthesiol Scand 1985; 29: 495-6. (32 year old woman with history of halothane hepatitis was on phenobarbital and carbamazepine and underwent enflurane anesthesia, developing fever on day 1 and jaundice on day 2 [bilirubin 5.8 mg/dL, AST 517 U/L, Alk P 1.5 times ULN], resolving within 6 weeks). 4036534
Eger EI 2nd, Smuckler EA, Ferrell LD, Goldsmith CH, Johnson BH. Is enflurane hepatotoxic? Anesth Analg 1986; 65: 21-30. (Reanalysis of data from Lewis et al [1983] suggested that enflurane was not the cause of liver injury in most cases; other causes being viruses, sepsis, shock and other medications). 3940466
Christ DD, Satoh H, Kenna JG, Pohl LR. Potential metabolic basis for enflurane hepatitis and the apparent cross-sensitization between enflurane and halothane. Drug Metab Dispos 1988; 16: 135-40. (Rats given anesthetics developed acylated hepatic microsomal protein adducts detectable by ELISA, halothane>> enflurane>> isoflurane). 2894942
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. ( Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 3 were attributed to halothane and 1 to isoflurane, none to the other halogenated anesthetics). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. ( 36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 16 were attributed to halothane [ranking #1] but none to the other halogenated anesthetics). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (The WHO database of fatal adverse drug reactions from 1968-2003 includes 4690 reports of drug induced liver fatality: halothane ranked fifth in frequency but most cases were reported before 1991). 16054882
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease collected in the US between 2003 and 2008, 2 cases were attributed to desflurane, 1 to sevoflurane, but none to enflurane). 18955056
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/0648003) (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to anesthetic agents).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 1 was attributed to halothane, 1 to isoflurane, but none to enflurane). 20949552
Safari S, Motavaf M, Seyed Siamdoust SA, Alavian SM. Hepatotoxicity of halogenated inhalational anesthetics. Iran Red Crescent Med J 2014; 16: e20153. (Review of hepatotoxicity of the volatile halogenated anesthetics). 25593732
Lin J, Moore D, Hockey B, Di Lernia R, Gorelik A, Liew D, Nicoll A. Drug-induced hepatotoxicity: incidence of abnormal liver function tests consistent with volatile anaesthetic hepatitis in trauma patients. Liver Int 2014; 34: 576-82. (Retrospective analysis of records from 1556 patients admitted to a trauma unit during 2008 identified 47 cases of possible volatile anesthetic related liver injury, including 12 who developed ALT levels above 200 U/L of whom 11 had fever and 6 eosinophilia, but none were jaundiced or developed acute liver failure). 23944929
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases of which 5 [3%] were attributed to halothane and caused acute liver failure, while no other volatile anesthetic was listed). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to isoflurane, 1 to sevoflurane, but none to halothane, enflurane or desflurane). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Enflurane: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=enflurane/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Enflurane: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=enflurane)